# Alpha Glucosidase Inhibitors

## OVERVIEW

Alpha glucosidase is an intestinal brush border enzyme responsible for the hydrolysis of disaccharides which is necessary for the absorption of starch, dextrins and disaccharides. Inhibition of this enzyme causes malabsorption and slowing of absorption of carbohydrates and decreases the postprandial rise in blood glucose. These drugs may also increase the release of glucagon-like peptide-1 (GLP-1) which may contribute to their glucosing lowering effects. Alpha glucosidase inhibitors have been shown to be effective in improving glycemic control in type 2 diabetes. Two alpha glucosidase inhibitors have been approved for use in the United States, acarbose (Precose) in 1995 and miglitol (Glyset) in 1996. While these two agents have a similar mechanism of action, they have different chemical structures and pharmacokinetics. Acarbose is a modified bacterial enzyme that is not appreciably absorbed, while miglitol is a synthetic pseudo polysaccharide that is absorbed from the gastrointestinal tract. Both drugs are taken three times daily with meals (with the first bite) and cause mild carbohydrate malabsorption. Common side effects of both agents are flatulence, abdominal bloating and discomfort and diarrhea. Ironically, acarbose which has little systemic absorption, has been clearly linked to rare instances of clinically apparent liver injury, while no specific instances of such injury have been attributed to miglitol. For this reason, these two agents are discussed separately and references to their safety and potential hepatotoxicity given with each agent.

Drug Class: Antidiabetic Agents

Drugs in the Subclass, Alpha Glucosidase Inhibitors: Acarbose, Miglitol

## ANNOTATED BIBLIOGRAPHY

References updated: 12 January 2021

Zimmerman HJ. Oral hypoglycemic agents and other diabetes therapy. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 575-9. (Textbook of hepatotoxicity published in 1999 mentions that several instances of serum enzyme elevations and at least two cases of liver injury with jaundice have been linked to acarbose use; no mention of miglitol).
Bhardwaj SS, Chalasani NP. Antidiabetic drugs. Cardiovascular and antidiabetic medications. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 611-7. (Review of hepatotoxicity published in 2007 mentions that acarbose has been associated with hepatocellular injury despite the fact that it is minimally absorbed, but that miglitol has not been implicated in causing liver injury).
Powers AC, D’Alessio D. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Hillal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 863-86. (Textbook of pharmacology and therapeutics).
Coniff RF, Shapiro JA, Seaton TB, Bray GA. (1995). Multicenter, placebo-controlled trial comparing acarbose (BAY g 5421) with placebo, tolbutamide, and tolbutamide-plus-acarbose in non-insulin-dependent diabetes mellitus. Am J Med. (Controlled trial of acarbose vs placebo with and without tolbutamide in 290 patients with diabetes; while overall rates of ALT elevations were similar with and without acarbose, elevations >3 times ULN occurred in 5 patients [4%] on acarbose and none on placebo; all abnormalities were reversible with discontinuation of treatment).
(1999). Miglitol for type 2 diabetes mellitus. Med Lett Drugs Ther. (Brief review of role of miglitol in type 2 diabetes; "increased aminotransferase activity has not been reported with miglitol"; otherwise, the average cost, efficacy and tolerance of miglitol are similar to acarbose).
Hedrington MS, Davis SN. (2019). Considerations when using alpha-glucosidase inhibitors in the treatment of type 2 diabetes. Expert Opin Pharmacother. (Review of the role of alpha glucosidase inhibitors in the therapy of type 2 diabetes mentions that side effects are largely gastrointestinal [diarrhea, abdominal pain, flatulence] and are transient and mostly dose dependent; no mention of ALT elevations or hepatotoxicity).
(2019). Drugs for type 2 diabetes. Med Lett Drugs Ther. (Concise review of the mechanisms of action, clinical efficacy, side effects and costs of currently available drugs for type 2 diabetes mentions that miglitol and acarbose must be taken with each meal and can lower HbA1c levels by 0.5-1.0%; side effects are not discussed).